# Teclistamab

## OVERVIEW

### Introduction

Teclistamab is a bispecific human monoclonal antibody to the B cell maturation antigen (BCMA) and CD3, which targets the antibody to T cells (T cell engager) and is used in the treatment of refractory or relapsing multiple myeloma. Teclistamab has major side effects including cytokine release syndrome as well as immune related conditions, including liver injury, which can be serious and even fatal.

### Background

Teclistamab (tech’ lis ta mab) is a human bispecific monoclonal antibody to the B cell maturation antigen (BCMA) and the CD3 cell surface antigen, which is used in the treatment of refractory or relapsing multiple myeloma. Teclistamab binds to BCMA which is prominently expressed on the surface of B cells and myeloma cells. Teclistamab also binds to CD3 which is expressed on activated T cells and thus brings them into contact with the bound BCMA expressing myeloma cells. This two-fold engagement of myeloma cells results in their rapid destruction. As a result of its demonstrated efficacy in a proportion of treated patients with refractory multiple myeloma in early phase trials, teclistamab was given accelerated approval for use in advanced refractory or relapsed multiple myeloma after at least 4 prior lines of therapy in the United States in 2022. Teclistamab is available in liquid solution in vials containing 30 mg in 3 mL (10 mg/mL) and 153 mg in 1.7 mL (90 mg/mL) under the brand name Tecvayli. The recommended regimen includes a step-up phase over one week to a maintenance dose of 1.5 mg/kg subcutaneously which is then continued once weekly until disease progression or intolerance. Pretreatment with corticosteroids, antihistamines and antipyretics are recommended, particularly with initial doses. Side effects are frequent and often severe including cytokine release syndrome in 72% of treated patients. Severe infections, neutropenia, hypersensitivity reactions, and immune related injury including neurotoxicity, renal toxicity and hepatotoxicity has also been described and the overall fatality rate is 5%. As a consequence, teclistamab is available only as part of a Risk Evaluation and Mitigation Strategy (REMS) that requires specific training, informed consent and adverse event reporting. Other common adverse events include fever, musculoskeletal pain, injection site reactions, nausea, diarrhea, and fatigue. Early recognition and prompt management of the adverse effects of teclistamab is an integral component of its proper use.

### Hepatotoxicity

In prelicensure studies, serum ALT elevations arose in 28% of patients receiving teclistamab and were above 5 times the upper limit of normal (ULN) in 2%. Elevations in total bilirubin arose in 6% of patients. In addition, immune mediated liver injury arose in a proportion of patients and was fatal in one. Despite these findings, the clinical features, timing and duration of liver injury due to teclistamab have not been described. Monitoring of liver tests is recommended at baseline and as clinically indicated during therapy. The clinical experience with teclistamab has been limited and the frequency and clinical features of the injury are not known.

The effects of teclistamab on hepatitis B virus (HBV) have not been reported as enrollment criteria in the clinical trials have usually excluded patients with chronic viral hepatitis.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury due to teclistamab is likely to be immunologically mediated.

### Outcome and Management

Guidelines for management of patients receiving teclistamab recommend monitoring of liver tests, and temporarily withholding therapy if ALT or AST elevations above 5 times the ULN arise and stopping therapy if ALT elevations accompanied by symptoms of hepatitis or jaundice arise or for any ALT or AST elevations above 20 times the ULN. Patients with suspected immune mediated hepatitis that does not resolve promptly with stopping teclistamab should be treated with immunosuppression.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Teclistamab – Tecvayli®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Teclistamab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Teclistamab | 2119595-80-9 (https://pubchem.ncbi.nlm.nih.gov/substance/381609131) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2023

Abbreviations used: BCMA, B cell maturation antigen; CD3, Cluster of differentiation-3.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/761291Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific reviews of the new drug application of teclistamab for safety and efficacy, mentions that adverse events were frequent including neutropenia, lymphopenia, thrombocytopenia, cytokine release syndrome [72%], neurotoxicity [13%] and gastrointestinal side effects; ALT elevations arose in 28% of patients but were above 5 times ULN in only 2%, although one patient died of suspected acute liver failure).
Pillarisetti K, Powers G, Luistro L, Babich A, Baldwin E, Li Y, Zhang X, et al. (2020). Teclistamab is an active T cell-redirecting bispecific antibody against B-cell maturation antigen for multiple myeloma. Blood Adv. (In vitro studies demonstrated that the bispecific monoclonal antibody teclistamab bound to and eliminated BCMA expressing myeloma cells resulting in release of cytokines).
Usmani SZ, Garfall AL, van de Donk NWCJ, Nahi H, San-Miguel JF, Oriol A, Rosinol L, et al. (2021). Teclistamab, a B-cell maturation antigen × CD3 bispecific antibody, in patients with relapsed or refractory multiple myeloma (MajesTEC-1): a multicentre, open-label, single-arm, phase 1 study. Lancet. (In a phase 1 safety and dose finding study of teclistamab in 157 patients with refractory multiple myeloma, the dose chosen for phase 2 studies was 1.5 mg subcutaneously once weekly after a step-up phase, which in 40 patients yielded a response rate of 65% and high rate of adverse events including cytokine release syndrome in 70%, neutropenia in 65% and ALT elevations in 9.6%, none of which were above 5 times ULN).
Moreau P, Garfall AL, van de Donk NWCJ, Nahi H, San-Miguel JF, Oriol A, Nooka AK, et al. (2022). Teclistamab in relapsed or refractory multiple myeloma. N Engl J Med. (Among 165 patients with refractory or relapsed multiple myeloma treated with teclistamab [1.5 mg weekly after a step-up phase], a complete response or better was achieved in 63% of patients and adverse events included cytokine release syndrome in 72%, neutropenia 71%, infections 70%, anemia 52%, thrombocytopenia 40%, and neurotoxic effects 14.5%; no mention of ALT elevations but one of 5 deaths considered due to teclistamab therapy was attributed to hepatic failure without specific details).
Kang C. (2022). Teclistamab: first approval. Drugs. (Summary of the chemistry, pharmacology, history of development, clinical efficacy and safety of teclistamab shortly after its approval for use in the US for refractory or relapsed multiple myeloma; no mention of ALT elevations or hepatotoxicity).
(2022). Teclistamab-cqyv (Tecvayli) for multiple myeloma. Med Lett Drugs Ther. (Review of the mechanism of action, clinical efficacy, safety and costs of teclistamab shortly after its approval for use in the US for refractory or relapsed multiple myeloma, mentions that hepatotoxicity can occur and liver tests should be monitored before and periodically during therapy).

## OTHER REFERENCE LINKS

1 Recent References on Teclistamab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Teclistamab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Teclistamab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Teclistamab)